# Procainamide

## OVERVIEW

### Introduction

Procainamide is an oral antiarrhythmic agent that has been in use for more than 60 years. Long term procainamide therapy is known to induce hypersensitivity reactions, autoantibody formation and a lupus-like syndrome but is a rare cause of clinically apparent acute liver injury.

### Background

Procainamide (proe kane' a mide) is an analogue of the local anesthetic procaine and has electrophysiological effects that resemble quinidine. Procainamide appears to act by blocking open sodium channels and outward potassium channels. As a consequence, it decreases cardiac automaticity, increases refractory periods and slows conduction. Procainamide was approved for use in the United States in 1950, and current indications include suppression of symptomatic premature ventricular contractions and life threatening ventricular tachycardia, as well as maintenance of normal sinus rhythm after conversion of atrial fibrillation or flutter. Because of its safety profile, procainamide is now rarely used and is recommended only for life-threatening ventricular arrhythmias. Procainamide was formerly available in capsules and tablets of 250, 375 and 500 mg generically and under the brand name Pronestyl and as extended release forms of 250, 500, 750 and 1,000 mg under the brand name Procanbid. Procainamide is currently available as a solution for intravenous infusion. The usual maintenance oral dose in adults is 500 to 1000 mg every 4 to 6 hours. The most common side effects include headache, nervousness, anxiety, nausea, decreased appetite, palpitations and disturbed sleep. Rare but potentially severe adverse events include aplastic anemia, agranulocytosis, drug hypersensitivity reactions, induction of autoantibodies including antinuclear antibody and drug induced lupus erythematosus.

### Hepatotoxicity

In clinical trials, procainamide was associated with a low rate of serum aminotransferase and alkaline phosphatase elevations. Despite wide scale use, procainamide has only rarely been linked to cases of clinically apparent liver injury. In reported cases, fever and mild symptoms arose within 1 to 3 weeks of starting (or within 1 day of restarting) procainamide, associated with a cholestatic pattern of serum enzyme elevations with mild or no jaundice (Case 1). Immunoallergic features were usually present (fever, rash, leukocytosis). In reported cases, fever resolved immediately and evidence of liver injury within a few days to weeks of stopping procainamide. Liver biopsy may how granulomas in addition to mild nonspecific changes. Interestingly, the hepatotoxicity of procainamide closely resembles that of quinidine, but there is no apparent cross sensitivity to the hepatic injury. In addition, up to 20% of patients on long term procainamide therapy develop autoantibodies, including ANA and LE prep positivity and a proportion develop a “lupus-like” syndrome. These autoimmune conditions, however, typically occur without an accompanying hepatitis, serum enzyme elevations or jaundice.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which procainamide causes liver injury is likely hypersensitivity. Procainamide is extensively metabolized in the liver which might result in production of an immunogenic metabolite.

### Outcome and Management

The liver injury due to procainamide is usually a part of a hypersensitivity reaction with fever, rash and fatigue and resolves rapidly with discontinuation. Rechallenge invariably leads to recurrence of the fever and liver test abnormalities and should be avoided. There does not appear to be cross sensitivity between hypersensitivity reactions to procainamide and those due to quinidine or other antiarrhythmics.

Drug Class: Antiarrhythmic Agents

## CASE REPORT

### Case 1. Acute hypersensitivity and liver injury after an infusion of procainamide.(1)

A 23 year old man with Wolff-Parkinson-White syndrome developed a fever and rash 6 hours after an infusion of procainamide (1.5 g intravenously), given as a part of a cardiac electrophysiological study. He had received procainamide three weeks previously to reverse a supraventricular tachycardia that was thereafter managed with oral nadolol (40 mg daily) until the planned cardiac study. He had no history of liver disease, alcohol abuse, risk factors for viral hepatitis or previous drug allergies. He took no other medications. On examination, he was febrile to 38.9 ^o^C and had a diffuse macular erythematous rash. There was slight tenderness over his liver. Laboratory testing showed a slight elevation in white blood cell count and elevations in liver tests (Table). Tests for hepatitis A and B were negative as were autoantibodies. He was monitored on no therapy and his symptoms resolved rapidly. The liver test abnormalities worsened for a few days and then began to improve.

#### Key Points

Medication: | Procainamide (1500 mg intravenously)
Pattern: | Mixed (R=2.9)
Severity: | 3+ (jaundice, prolongation of hospitalization)
Latency: | 6 hours
Recovery: | Not given
Other medications: | Nadolol

#### Laboratory Values

Time After Starting | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | 46 | 73 | 0.3
Procainamide infusion followed by fever 6 hours later
1 day | 156 | 99 | 5.3 | Temp 38.9 ^o^C
2 days | | | 6.5
3 days | 101 | 93 | 3.6
4 days | 156 | | 3.1
5 days | 394 | 252 | 2.4 | Discharged
6 days | 329 | 230 | 1.8
9 days | 151 | 130 | 1.0
Normal | <53 | <110 | <1.2

#### Comment

This patient developed a hypersensitivity reaction to a single infusion of procainamide (a second exposure) with fever, rash and leukocytosis (eosinophils count was not given), followed by jaundice and a mixed pattern of serum enzyme elevations. Most instances of procainamide associated liver injury have been associated with fever and other manifestations of hypersensitivity. The pattern of liver enzyme elevations is usually cholestatic and the injury usually self-limiting and mild.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Procainamide – Generic, Pronestyl®

DRUG CLASS

Antiarrhythmic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Procainamide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Procainamide | 51-06-9 | C13-H21-N3-O

## CITED REFERENCE

1 Worman HJ, Ip JH, Winters SL, Tepper DC, Gomes AJ. (1992). Hypersensitivity reaction associated with acute hepatic dysfunction following a single intravenous dose of procainamide. J Intern Med.

## ANNOTATED BIBLIOGRAPHY

References updated: 10 July 2020

Abbreviations: ANA, antinuclear antibody; LE prep, Lupus erythematosus preparation.

Zimmerman HJ. Antiarrhythmics. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 642-4. (Expert review of hepatotoxicity of antiarrhythmics published in 1999; “Hepatic injury caused by this drug appears to be rare” 6 cases having been reported).
De Maurzio DH, Navarro VJ. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 519-40. (Review of hepatotoxicity of antiarrhythmics mentions that liver injury from procainamide is rare and generally mild with features of hypersensitivity).
Knollman BC, Roden DM. Anti-arrhythmic drugs. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 547-72. (Textbook of pharmacology and therapeutics).
Bakos AC, Askey JM. (1952). Fever due to procaine amide hydrochloride therapy. J Am Med Assoc. (58 year old woman developed fever and nausea 11 days after starting procainamide, resolving promptly on stopping and recurring after a single dose; liver tests were not done).
Hellman E. (1952). Allergy to procaine amide. J Am Med Assoc. (53 year old man developed rash within a day of starting procainamide followed by fever, adenopathy and eosinophilia; liver tests not done).
McGarry JJ. (1952). Chills and fever due to procaine amide hydrochloride therapy. N Engl J Med. (57 year old man developed recurrent fevers within one week of starting procainamide, resolving rapidly with stopping and recurring within 24 hours of rechallenge; no mention of liver tests or jaundice; negative patch and skin tests).
Luton EF. (1959). Febrile reaction to procainamide therapy. J Am Med Assoc. (61 year old man developed fever within a day of starting procainamide followed by fatigue, resolving within 24 hours of stopping with 3 subsequent positive rechallenges [fever]; no mention of liver tests).
Ladd AT. (1962). Procainamide-induced lupus erythematosus. N Engl J Med. (49 year old man developed intermittent rash and then arthralgias 4 months after starting procainamide with low grade fever, pleurisy, lupus erythematosus prep and ANA positivity, resolving with stopping and recurrence of fever [without LE prep positivity] 3 days after restarting procainamide).
King JA. (1963). Blountre Jr. An unexpected reaction to procainamide. JAMA. (78 year old woman with recurrent bouts of fever and painful hepatomegaly occurring after taking procainamide with two positive rechallenges, ALT rising to 85-185 U/L during episodes, but normal bilirubin and Alk P).
Colman RW, Sturgill BC. (1965). Lupus-like syndrome induced by procainamide: association with anti-DNA antibody. Arch Intern Med. (40 year old woman developed arthritis 4 months after starting procainamide; at 6 months ANA 1:4096, positive LE cell preps [AST and bilirubin normal]; symptoms and ANA had resolved 7 months after stopping).
Kaplan JM, Wachtel HL, Czarnecki SW, Sampson JJ. (1965). Lupus-like illness precipitated by procainamide hydrochloride. JAMA. (4 female patients, ages 47-70 years, developed arthralgias after 4-20 weeks of procainamide therapy with pleurisy, LE prep and ANA positivity, normal ALT and bilirubin, resolving in 8-24 weeks, rapid recurrence upon rechallenge).
Rosin JM. (1967). Vasculitis following procaine amide therapy. Am J Med. (53 year old man with atherosclerosis developed cyanosis and vasculitis in both hands 4 weeks after starting procainamide; positive LE prep resolved upon stopping, but fingers were subsequently lost from gangrene).
Lappat EJ, Cawein MJ. (1968). A familial study of procainamide-induced systemic lupus erythematosus. A question of pharmacogenetic polymorphism. Am J Med. (51 year old woman developed arthritis 5 months after starting procainamide [LE prep and ANA positive], resolving upon stopping, patients mother and 1 of 3 children were ANA positive and had nuclear phagocytosis on LE preps).
Dubois EL. (1969). Procainamide induction of a systemic lupus erythematosus-like syndrome. Presentation of six cases, review of the literature, and analysis and followup of reported cases. Medicine (Baltimore). (Extensive review of literature [55 cases] and description of 6 new cases, 6 patients with lupus-like syndrome after procainamide therapy; 5 men and 1 women, ages 7 to 77 years, treated for 1-72 months [mean=5], arthralgias in 92%, fever 39%, LE prep present 94%; skin rash less common than with idiopathic lupus and renal involvement very rare even on autopsy).
Molina J, Dubois EL, Bilitch M, Bland SL, Friou GJ. (1969). Procainamide-induced serologic changes in asymptomatic patients. Arthritis Rheum. (Among 22 patients treated with procainamide for >6 weeks, 17 [77%] developed LE prep positivity and 2 [10%] lupus-like syndrome).
(1970). Drug-induced lupus syndromes. Br Med J. (Editorial on drug induced lupus syndromes focusing upon hydralazine, procainamide, isoniazid, and anticonvulsants).
Blomgren SE. (1973). Drug-induced lupus erythematosus. Semin Hematol. (Review of drugs that cause a lupus-like syndrome, focusing upon hydralazine and procainamide in whom >10% developed lupus and >50% ANA positivity; syndrome also reported with isoniazid, penicillin, anticonvulsants and chlorpromazine).
Farber HI. (1974). Fever, vomiting, and liver dysfunction with procainamide therapy. Postgrad Med. (58 year old developed fever 3 weeks after starting procainamide [ALT 140 U/L, Alk P 14.4 BU, and bilirubin 2.0 mg/dL], resolving rapidly on stopping drug).
Henningsen NC, Cederberg A, Hanson A, Johansson BW. (1975). Effects of long-term treatment with procaine amide. A prospective study with special regard to ANF and SLE in fast and slow acetylators. Acta Med Scand. (Among 42 patients treated with procainamide for >3 months, 35 [83%] developed ANA positivity and 12 [29%] a lupus-like syndrome; more likely to occur in slow acetylators).
Woosley RL, Drayer DE, Reidenberg MM, Nies AS, Carr K, Oates JA. (1978). Effect of acetylator phenotype on the rate at which procainamide induces antinuclear antibodies and the lupus syndrome. N Engl J Med. (Among 20 patients treated with procainamide chronically, 18 developed ANA positivity [90%], but time to positivity was sooner among slow acetylators [50% positive by 2.9 vs 7.3 months]).
Rotmensch HH, Yust I, Siegman-Igra Y, Liron M, Ilie B, Vardinon N. (1978). Granulomatous hepatitis: a hypersensitivity response to procainamide. Ann Intern Med. (63 year old man developed fatigue and fever 2 weeks after starting procainamide followed by pruritus [bilirubin 2.0 mg/dL, Alk P 5 times ULN, ALT 130 U/L, LE prep and ANA negative], resolving rapidly on stopping; biopsy showed granulomas, positive rechallenge with fever and ALT elevation [62 U/L]).
Bernstein RE. (1979). Procainamide, acetylprocainamide, and drug-induced lupus erythematosus. Lancet. (Letter arguing that autoantibody induction by procainamide therapy is due to its slow metabolism by N-acetyltransferase and that acetylprocainamide would be better tolerated).
Rotmensch HH, Weintraub M, Sofferman G, Livni E, Klejman A, Liron M. (1981). Experience with immunological tests in drug-induced hepatitis. Z Gastroenterol. (Experience in using mast cell degranulation tests to validate causality of drug induced liver disease, including patient with procainamide induced liver injury: same case as in Rotmensch 1978).
McMaster KR, Hennigar GR. (1981). Drug-induced granulomatous hepatitis. Lab Invest. (Analysis of 95 cases of granulomatous hepatitis [6% of liver biopsies]; 29% due to drugs including 1 attributed to procainamide arising within 1 week and with fever but no rash, eosinophilia nor ANA reactivity).
Kumar KL, Reuler JB. (1986). Drug fever. West J Med. (Review of the causes and forms of drug fever; most common is hypersensitivity reactions such as occurs with procainamide).
Knox JP, Welykyj SE, Gradini R, Massa MC. (1988). Procainamide-induced urticarialvasculitis. Cutis. (Two male patients, aged 70 and 74 years, developed urticaria and vasculitis 7 months and 3 years after starting procainamide with ANA positivity, resolving 3-4 days after stopping procainamide; liver tests normal).
Ahn CS, Tow DE. (1990). Intrahepatic cholestasis due to hypersensitivity reaction to procainamide. Arch Intern Med. (71 year old man developed fever 4 days after starting procainamide with rise in serum bilirubin [0.3 to 13.0 mg/dL], ALT [14 to 63 U/L] and Alk P [92 to 734 U/L], jaundice persisting for more than 2 weeks, resolution not documented).
Worman HJ, Ip JH, Winters SL, Tepper DC, Gomes AJ. (1992). Hypersensitivity reaction associated with acute hepatic dysfunction following a single intravenous dose of procainamide. J Intern Med. (23 year old man developed fever and rash 4 hours after an infusion of procainamide [second exposure] and in next few days bilirubin rose from 0.3 to 6.5 mg/dL, ALT 46 to 394 U/L, Alk P 73 to 252 U/L, resolving rapidly thereafter: Case 1).
Chuang LC, Tunier AP, Akhtar N, Levine SM. (1993). Possible case of procainamide-induced intrahepatic cholestatic jaundice. Ann Pharmacother. (77 year old woman became obtunded 6 weeks after starting procainamide [bilirubin 5.2 rising to 10.1 mg/dL, ALT 382 U/L, Alk P 1071 U/L, ANA 1:40], macular rash, improving upon stopping procainamide and with prednisone therapy, but incomplete follow up).
Rubin RL. (2005). Drug-induced lupus. Toxicology. (More than 40 medications have been linked to drug induced lupus; up to 20% of patients on long term procainamide will develop lupus-like syndrome; animal models have used a hydroxylamine derivative of procainamide which may act as an immunogenic hapten).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, no cases were attributed to procainamide).
(2007). Drugs for cardiac arrhythmias. Treat Guidel Med Lett. (Concise review of drugs for arrhythmias; procainamide is considered a second line, or alternative choice for both ventricular and atrial arrhythmias; side effects are common and can include lupus-like syndrome, confusion, dyspepsia, rash, hypotension and blood dyscrasias).
(2010). Treatment of atrial fibrillation. Treat Guidel Med Lett. (Concise review of efficacy and safety of drugs for atrial fibrillation; first line agents include amiodarone, dronedarone, propafenone and flecainide; procainamide can prolong the QTc interval and is not recommended).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to procainamide).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 7 cases [0.8%] were attributed to antiarrhythmics, [5 to amiodarone, 2 to dronedarone], but none to procainamide).
Arnaud L, Mertz P, Gavand PE, Martin T, Chasset F, Tebacher-Alt M, Lambert A, et al. (2019). Drug-induced systemic lupus: revisiting the ever-changing spectrum of the disease using the WHO pharmacovigilance database. Ann Rheum Dis. (Among 8136 reports of drug induced systemic lupus reported to the VigilBase registry of drug adverse events between 1967 and 2018, 118 suspect drugs were identified the most frequent being infliximab [1053], adalimumab [926], etanercept [691], procainamide [518: 6%] and hydralazine [444: 5.1%]; 81% of cases in women, median age 49 years, median onset 172 days).

## OTHER REFERENCE LINKS

1 Recent References on Procainamide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Procainamide/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Procainamide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Procainamide)